# Vitamin C

## OVERVIEW

### Introduction

Vitamin C (ascorbic acid) is a water soluble vitamin found in citrus fruits and green vegetables and deficiency of which is the cause of scurvy. There is no evidence that vitamin C, in physiologic or in moderately high doses, causes acute liver injury or jaundice.

### Background

Vitamin C is a water soluble vitamin known chemically as L-ascorbic acid (as kore' bik as' id). The major role of ascorbic acid is as an electron donor and intracellular antioxidant protecting critical intracellular molecules and enzymes systems against reactive oxygen species. Vitamin C also plays a role as a cofactor in many biochemical synthetic reactions, in collagen cross linking, the synthesis of neuropeptides and hormones, and in non-heme iron absorption. Vitamin C is found in many foods, particularly citrus fruits, green vegetables, tomatoes and potatoes. The recommended daily allowance of vitamin C is 90 mg in adult men and 70 mg in women, an amount that is provided by most American diets. Intakes of more than 2 grams daily are considered excessive and should be avoided. Vitamin C deficiency is the cause of scurvy which is marked by fatigue, spongy gums, loss of teeth, ecchymosis, petechiae and excessive bleeding including bleeding from the gums, into joints and into internal organs. Scurvy is now rare in the developed world, seen predominantly with severe malnutrition and chronic alcoholism. Vitamin C is available in many over-the-counter forms in concentrations ranging from 25 to 1000 mg and is a component of virtually all multivitamins, typically in concentrations of 60 to 180 mg. Parenteral formulations are available for administration with parenteral nutrition. Despite many claims, there is no convincing evidence that vitamin C supplementation decreases the rate of cancer, heart attacks or strokes or prevents common colds or other viral infections. Physiologic and even excessive intakes up to 2 grams daily have virtually no side effects. Higher doses of vitamin C can be associated with diarrhea, nausea, abdominal discomfort, flushing, dizziness and headache and may be associated with transient serum aminotransferase elevations.

### Hepatotoxicity

Neither normal nor moderately high intakes of vitamin C are associated with liver injury or liver test abnormalities. In long term clinical trials, serum enzyme and bilirubin elevations were no more frequent with vitamin C therapy than with placebo. Indeed, in many animal models, vitamin C is protective against hepatotoxic substances and provides antioxidant and cytoprotective activity to hepatocytes. High doses of vitamin C, however, can have pro-oxidant activity and have been associated with exacerbation of hemolysis and worsening of oxalate renal stone formation. Single large doses of vitamin C can cause symptoms of nausea, abdominal pain and diarrhea and higher doses have been reported to result in serum ALT elevations, but not to clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The serum ALT elevations that occur with extremely high doses of vitamin C are likely due to a direct but minimal toxic effect on the liver. The injury is, however, short lived and has not been linked to cases of acute or chronic hepatitis, acute liver failure or cirrhosis.

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin B, Vitamin D, Vitamin E, Vitamin K, Folate, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin C – Generic, Combination Products

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vitamin+C)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ascorbic Acid | 50-81-7 | C6-H8-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 27 May 2021

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss vitamin C).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins and minerals).
Jacob RA. Vitamin C. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998; pp 467-84. (Textbook of nutrition).
Food and Nutrition Board, Institute of Medicine. DRI dietary reference intakes: for vitamin C, vitamin E, selenium and carotenoids. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on dietary reference values for vitamin C intake, replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/VitaminC-HealthProfessional/ (Fact sheet on vitamin C maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Dykes MH, Meier P. (1975). Ascorbic acid and the common cold. Evaluation of its efficacy and toxicity. JAMA. (Review of the literature on the safety and efficacy of high doses of vitamin C in prevention and treatment of the common cold found little or no evidence of either efficacy or significant toxicity).
Rivers JM. (1987). Safety of high-level vitamin C ingestion. Ann N Y Acad Sci. (Review of literature on toxicity of high doses of vitamin C focusing on calcium-oxalate stones, uric acid excretion, iron overload and increased mutagenic activity; no mention of ALT elevations or hepatotoxicity).
Bendich A, Langseth L. (1995). The health effects of vitamin C supplementation: a review. J Am Coll Nutr. (The safety of higher doses of vitamin C has been shown in 8 placebo controlled trials).
Levine M, Rumsey SC, Daruwala R, Park JB, Wang Y. (1999). Criteria and recommendations for vitamin C intake. JAMA. (Review of the role of vitamin C in metabolic pathways, its absorption and pharmacokinetics, adverse events and beneficial dose effects).
Shekelle P, Morton S, Hardy ML. (2003). Effect of supplemental antioxidants vitamin C, vitamin E, and coenzyme Q10 for the prevention and treatment of cardiovascular disease. Evid Rep Technol Assess (Summ). (A systematic review of four placebo controlled trials of vitamin C for its effects in decreasing the rate of cardiovascular disease showed no evidence of benefit, but also no evidence for toxicity of vitamin C).
Shekelle P, Hardy ML, Coulter I, Udani J, Spar M, Oda K, Jungvig LK, et al. (2003). Effect of the supplemental use of antioxidants vitamin C, vitamin E, and coenzyme Q10 for the prevention and treatment of cancer. Evid Rep Technol Assess (Summ). (A systematic review of placebo controlled trials of vitamin C for its effects in decreasing the rate of cancer showed no evidence of benefit, but also no evidence for toxicity of vitamin C).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamins including vitamin C).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin, but none were attributed to any other vitamin including vitamin C).
Doseděl M, Jirkovský E, Macáková K, Krčmová LK, Javorská L, Pourová J, Mercolini L, et al., On Behalf Of The Oemonom. (2021). Vitamin C-sources, physiological role, kinetics, deficiency, use, toxicity, and determination. Nutrients. (Review of the physiologic role, kinetics, distribution, medical uses and safety of vitamin C mentions that it has antioxidant activities at physiologic levels, but pro-oxidant actions at high levels and high oral or intravenous intake of vitamin C can exacerbate hemolysis and oxalate kidney stone formation; no mention of hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Vitamin C: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamin%20C/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vitamin C: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin%20C)